# Momelotinib

## OVERVIEW

### Introduction

Momelotinib is a small molecule Janus kinase inhibitor that is used in the treatment of intermediate or high risk, primary or secondary myelofibrosis. Momelotinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy and has also been linked to instances of clinically apparent acute liver injury including reactivation of hepatitis B.

### Background

Momelotinib (moe” me, loe’ ti nib) is an orally available, small molecular inhibitor of Janus kinase subtype 1 and 2 (JAK1/2) including mutant JAK2^V617F^ and is used to treat resistant forms of myelofibrosis including secondary forms related to polycythemia vera and essential thrombocythemia. Myelofibrosis is a cancerous or pre-cancerous condition of the bone marrow that results in progressive bone marrow failure with enlargement of the spleen, anemia, neutropenia and thrombocytopenia. JAK1 and JAK2 are non-receptor tyrosine kinases that are critical components of pathways that lead to production and secretion of hematologic growth factors and inflammatory cytokines. These pathways are important in hematologic cell differentiation and proliferation, in cytokine-production, and inflammatory reactions. Mutations in JAK genes are frequent in patients with myelofibrosis including JAK2^V617F^ which is found in more than 90% of patients with polycythemia vera and at least 50% of those with essential thrombocythemia. Inhibition of these kinases can result in antiproliferative and apoptotic effects in malignant cells. Momelotinib has been shown to improve symptoms, cause shrinkage of spleen size, and decrease circulating cytokine levels in patients with myelofibrosis independent of the known presence of Janus kinase mutations. Momelotinib was approved for use in the United States in 2023 for therapy of intermediate and high risk primary or secondary myelofibrosis with anemia. Momelotinib is available in capsules of 100, 150, and 200 mg under the brand name Ojjaara. The recommended initial dose is 200 mg once daily. Dose adjustments for hepatic dysfunction and for adverse reactions are recommended. Common side effects include myelosuppression, anemia, thrombocytopenia, fatigue, diarrhea, bruising, dizziness, peripheral neuropathy, dyspnea, headache and fatigue. Less common but potentially severe adverse events include risk of infections including reactivation of viruses, peripheral neuropathy, severe thrombocytopenia, and neutropenia. All small molecule JAK inhibitors have safety labeling for increased risk of major cardiovascular adverse events, increased mortality, venous and arterial thromboses, secondary malignancies, and increased risk of infection.

### Hepatotoxicity

In the published preregistration clinical trials of momelotinib, rates of serum ALT or AST elevations ranged from 21% to 31% and were above 5 times the upper limit of normal (ULN) in 0.5% to 2.0%, and above 20 times ULN in 0.5%. Two of 448 momelotinib treated patients evaluated in the safety cohort developed clinically apparent, but self-limiting liver injury with jaundice. A third patient developed liver injury with jaundice that appeared to be due to reactivation of hepatitis B. The liver injury was typically hepatocellular without immune allergic or autoimmune features, arising after 2 to 4 months of therapy, and resolving soon after drug discontinuation. Peak ALT elevations ranged from 308 to 1178 U/L and peak bilirubin from 2.3 to 7.0 mg/dL. There were no deaths from hepatic failure. Since its approval and more widespread clinical use, there have been no further reports of serum enzyme or bilirubin elevations or instances of clinically apparent liver injury, but it has been available for a limited time only.

Likelihood score: D (possible cause of clinically apparent liver injury including reactivation of hepatitis B).

### Mechanism of Injury

Momelotinib therapy has been clearly linked to serum enzyme elevations and to rare instances of clinically apparent liver injury. It is metabolized in the liver, and liver injury may be due to its metabolism to an immunogenic or toxic intermediate. Momelotinib is a weak inducer of CYP 2B6 and competes for hepatic uptake for the organic anion transporting polypeptide and hepatocyte secretion for the breast cancer resistance protein and thus may have significant drug-drug interactions. Because of its effects on intracellular signaling involved in immune responses, momelotinib (and other JAK inhibitors) may be capable of increasing hepatitis B viral replication, which can result in clinically apparent reactivation of hepatitis B.

### Outcome and Management

Momelotinib has been clearly linked to serum aminotransferase elevations and significant liver injury. For this reason, routine monitoring of liver tests is recommended in the product label every month for six months, and “as needed” thereafter. Serum aminotransferase elevations above 5 times ULN should lead to dose reduction or temporary cessation until they fall into the normal or near normal range, or another cause for the elevations is found. ALT or AST elevations above 20 times ULN or any elevations accompanied by jaundice or symptoms should lead to discontinuation. Because of the possibility of reactivation of hepatitis B, it is appropriate to screen patients for hepatitis B markers before starting momelotinib and, if HBsAg or anti-HBc are present, providing antiviral prophylaxis or monitoring for reactivation during therapy. There does not appear to be cross reactivity in risk for hepatic injury among the various JAK kinase inhibitors, but few instances have been studied.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Janus Kinase Inhibitors: Abrocitinib, Baricitinib, Deucravacitinib, Fedratinib, Pacritinib, Ritlecitinib, Ruxolitinib, Tofacitinib, Upadacitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Momelotinib – Ojjaara®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Momelotinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Momelotinib | 1056634-68-4 | C23-H22-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 28 December 2023

Abbreviations: JAK, Janus kinase; STAT, signal transducer activator of transcription.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as momelotinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not momelotinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216873Orig1s000IntegratedR.pdf (Integrated FDA review of the data on safety and efficacy of momelotinib that formed the basis of its approval, mentions that ALT elevations arose in 22- 31% of patients, were above 5 times ULN in 0.5-2.0%, and that among 448 patients treated, there were 8 cases of suspected drug induced liver injury, 3 of which were considered probable or highly likely: 2 women and 1 man, ages 59, 77 and 54 years, with onset after 59, 112 and 54 days, and peak ALT 1178, 483 and 308 U/L, Alk P 617 566, and 83 U/L, bilirubin 7.0, 2.3 and 4.0 mg/dL, and all improving once momelotinib was stopped, one with apparent reactivation of hepatitis B with evidence of cirrhosis).
Verstovsek S, Courby S, Griesshammer M, Mesa RA, Brachmann CB, Kawashima J, Maltzman JD, et al. A phase 2 study of momelotinib, a potent JAK1 and JAK2 inhibitor, in patients with polycythemia vera or essential thrombocythemia. Leuk Res. 2017;60:11–17. (Among 39 patients with polycythemia or essential thrombocythemia treated with momelotinib [100 or 200 mg] once daily for 24 weeks, only 2 patients had a cytological response while 80% of patients had adverse events including headache, dizziness, somnolence, nausea and fatigue; no mention of ALT elevations or hepatotoxicity). 28622623
Mesa RA, Kiladjian JJ, Catalano JV, Devos T, Egyed M, Hellmann A, McLornan D, et al. SIMPLIFY-1: a phase III randomized trial of momelotinib versus ruxolitinib in Janus kinase inhibitor-naïve patients with myelofibrosis. J Clin Oncol. 2017;35:3844–3850. (Among 432 patients with high or intermediate risk myelofibrosis treated with momelotinib [200 mg, once daily] or ruxolitinib [20 mg, twice daily] for 24 weeks, spleen size decreased in 26.5% vs 29% and adverse events arose in 92% vs 95%, serious adverse events in 23% vs 18%, resulting in discontinuations in 13% vs 6%, and peripheral neuropathy in 10% vs 5%, while there were no hepatic serious adverse events or deaths; no mention of ALT elevations ). 28930494
Harrison CN, Vannucchi AM, Platzbecker U, Cervantes F, Gupta V, Lavie D, Passamonti F, et al. Momelotinib versus best available therapy in patients with myelofibrosis previously treated with ruxolitinib (SIMPLIFY 2): a randomised, open-label, phase 3 trial. Lancet Haematol. 2018;5:e73–e81. (Among 156 patients with myelofibrosis and an inadequate response to or intolerance of ruxolitinib treated with momelotinib [200 mg once daily] or “best available therapy” for 24 weeks, reduction in spleen size [by 35% or greater] was achieved in 7% vs 6% and adverse events arose in 97% vs 89%, serious adverse events in 35% vs 23%, peripheral neuropathy in 11% vs none, deaths in 6% vs 8%, and there were no hepatic deaths or serious adverse events noted; no mention of ALT elevations). 29275119
Coltro G, Vannucchi AM. The safety of JAK kinase inhibitors for the treatment of myelofibrosis. Expert Opin Drug Saf. 2021;20:139–154. (Extensive review of the mechanism of action, rationale for use, current status, and safety of JAK kinase inhibitors for myelofibrosis including 2 FDA approved agents [ruxolitinib and fedratinib] and 2 in clinical development [pacritinib and momelotinib], focusing on common hematologic and gastrointestinal adverse events and special concerns on increased rates of infections, peripheral neuropathy and secondary cancer including lymphomas; no discussion of hepatotoxicity and ALT elevations mentioned only for fedratinib). 33327810
Verstovsek S, Gerds AT, Vannucchi AM, Al-Ali HK, Lavie D, Kuykendall AT, Grosicki S, et al; MOMENTUM Study Investigators. Momelotinib versus danazol in symptomatic patients with anaemia and myelofibrosis (MOMENTUM): results from an international, double-blind, randomised, controlled, phase 3 study. Lancet. 2023;401(10373):269–280. (Among 195 patients with intermediate or high risk symptomatic myelofibrosis treated with momelotinib [200 mg once daily] or danazol [300 mg twice daily] for 24 weeks, symptom improvement occurred in 25% vs 9% and transfusion independence in 30% vs 20%, while adverse event rates were similar 94% vs 95%, serious adverse events 35% vs 40%, discontinuations in 18% vs 23%, fatal outcome in 12% vs 17%, and ALT elevations in 7% vs 8%). 36709073
Gerds AT, Verstovsek S, Vannucchi AM, Al-Ali HK, Lavie D, Kuykendall AT, Grosicki S, et al. Momelotinib versus danazol in symptomatic patients with anaemia and myelofibrosis previously treated with a JAK inhibitor (MOMENTUM): an updated analysis of an international, double-blind, randomised phase 3 study. Lancet Haematol. 2023;10:e735–e746. (Among 82 patients who continued on or were crossed over to open-label momelotinib after participation in a controlled trial [Verstovek 2023], rates of symptom improvement [45-50%] and transfusion independence [55-60%] increased while “there were no new safety signals”, no liver related serious adverse events or fatalities, although therapy was discontinued in one subject because of ALT and AST elevations [no details given]; no mention of rates of ALT elevations). 37517413

## OTHER REFERENCE LINKS

Recent References on Momelotinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Momelotinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Momelotinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Momelotinib)